# Cladribine

## OVERVIEW

### Introduction

Cladribine is a purine analogue and antineoplastic agent that is used intravenously in high doses as therapy of hairy cell leukemia and orally as tablets in cycles as therapy of refractory forms of relapsing multiple sclerosis. Cladribine when given in solution intravenously or as tablets by mouth has been associated with a minimal rate of serum enzyme elevations during therapy and with rare instances of clinically apparent acute liver injury with jaundice.

### Background

Cladribine (klad' ri been) is a purine analogue (2-chlorodeoxyadeosine) that is used intravenously in the treatment of hairy cell leukemia and orally as tablets given in cycles as therapy of relapsing multiple sclerosis. Cladribine is a chlorodinated derivative of adenine which is converted intracellularly to the cladribine triphosphate, which is believed to compete with adenine triphosphate in DNA synthesis and cause cell necrosis. Lymphocytes are particularly susceptible to the effects of cladribine. Cladribine was found to have marked activity against hairy cell leukemia and was approved for this use in the United States in 1993. Intravenously and subcutaneously administered cladribine has been used off-label to treat low grade lymphomas and other hematologic malignancies, but its current formal indications are limited to therapy of active hairy cell leukemia. Cladribine is available as a solution for injection generically and under the trade name Leustatin. The typical dose regimen is a single course of 0.9 mg/m^2^ intravenously once daily for 7 days. Repeat courses are recommended only for patients who had an initial response and later relapsed.

In addition, cladribine given orally in two cycles of 4 to 5 days over the course of a year followed by a similar course during a second year has been shown to decrease the annualized risk of relapse in multiple sclerosis. Oral cladribine was approved for use in adults with relapsing multiple sclerosis in 2018 and is available in tablets of 10 mg under the brand name Mevenclad. The recommended dose is based upon body weight and is given in cycles of 4 to 5 days twice yearly for two years for a total cumulative dose of 3.5 mg/kg.

Common side effects of cladribine include bone marrow suppression, leucopenia, fever, infections, nausea, vomiting, anorexia, diarrhea, headache, fatigue, and skin rash. In addition, opportunistic viral infections are common during and after cladribine therapy and appropriate vaccination is recommended before its use. In high doses, above what is recommended for hairy cell leukemia, cladribine has been reported to have acute neurologic toxicity.

### Hepatotoxicity

In clinical trials, cladribine was associated with low rates of mild to moderate elevations in serum enzymes or bilirubin levels during or after therapy. However, at least one case of fatal reactivation of hepatitis B occurred. Since its approval and more wide scale use in multiple sclerosis there have been rare reports of clinically apparent liver injury attributed to its use. However, in most cases other agents used for multiple sclerosis were being given and the injury was not clearly due to cladribine. Most frequently, patients had received 3 to 5 days of high dose intravenous corticosteroids as therapy of an acute relapse just before cladribine was started. The subsequent injury resembled an acute hepatitis, with marked hepatocellular enzyme elevations arising within 3 to 8 weeks of the intravenous corticosteroids. In some instances, cladribine was restarted without recurrence of the hepatocellular injury.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The lack of hepatotoxicity of cladribine in early studies may relate to the short duration of therapy, low doses used, and its minimal hepatic metabolism. Subsequently, the liver injury is of uncertain cause. However, the lymphopenia induced by cladribine is likely the cause of reactivation of hepatitis B.

Drug Class: Antineoplastic Agents, Antimetabolites; Multiple Sclerosis Agents

Other Drugs that are Purine Analogues: Azathioprine, Cladribine, Clofarabine, Fludarabine, Mercaptopurine, Nelarabine, Pentostatin, Thioguanine

Multiple Sclerosis Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cladribine – Generic, Leustatin®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cladribine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cladribine | 4291-63-8 | C10-H12-Cl-N5-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 01 December 2025

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 mentions that fludarabine and cladribine were new purine analogues that had yet to be implicated in causing hepatic injury).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of anticancer agents does not discuss cladribine).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1167-203. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/022561Orig1s000MedR.pdf (FDA website with the clinical review of efficacy and safety data submitted in support of the approval of an oral cladribine as therapy of multiple sclerosis, mentions a fatal case of reactivation of hepatitis B during therapy but in the largest randomized controlled trial, the rates of liver test abnormalities were similar in cladribine vs placebo recipients with any ALT elevation in 32% vs 33% and elevations above 3 times ULN in 7.5% vs 8%; among 5 instances of ALT elevations identified in monotherapy studies of cladribine, all resolved after treatment discontinuation and none were associated with jaundice).
Piro LD, Carrera CJ, Carson DA, Beutler E. Lasting remissions in hairy-cell leukemia induced by a single infusion of 2-chlorodeoxyadenosine. N Engl J Med 1990; 322: 1117-21. (Among 12 adults with hairy cell leukemia treated with a single 7 day course of cladribine, all responded and 11 had a long term complete remission; side effects included fever, but no patient developed liver test abnormalities). 1969613
Estey EH, Kurzrock R, Kantarjian HM, O'Brien SM, McCredie KB, Beran M, Koller C, et al. Treatment of hairy cell leukemia with 2-chlorodeoxyadenosine (2-CdA). Blood 1992; 79: 882-7. (Among 46 patients with hairy cell leukemia treated with a single 7 day course of cladribine, 78% had a complete response; side effects included neutropenia, fever, infections within the first month, but there were no other systemic side effects and no mention of ALT abnormalities of liver related side effects). 1346577
Piro LD, Ellison DJ, Saven A. The Scripps Clinic experience with 2-chlorodeoxyadenosine in the treatment of hairy cell leukemia. Leuk Lymphoma 1994; 14 Suppl 1: 121-5. (Among 144 patients with hairy cell leukemia treated with cladribine, 82% achieved a complete remission and side effects were few, but included fever in 42%; no mention of ALT abnormalities or hepatotoxicity). 7820043
Sipe JC, Romine JS, Koziol JA, McMillan R, Zyroff J, Beutler E. Cladribine in treatment of chronic progressive multiple sclerosis. Lancet 1994; 344: 9-13. (52 patients with multiple sclerosis were treated with 4 courses of intravenous cladribine or placebo; acute adverse events included 2 cases of herpes zoster and one case each of transient bone marrow suppression, fulminant acute hepatitis B, and salmonella enteritis). 7912347
Juliusson G, Heldal D, Hippe E, Hedenus M, Malm C, Wallman K, Stolt CM, et al. Subcutaneous injections of 2-chlorodeoxyadenosine for symptomatic hairy cell leukemia. J Clin Oncol 1995; 13: 989-95. (Among 73 patients with hairy cell leukemia treated with subcutaneous rather than intravenous cladribine, complete responses occurred in 81% of patients and 38% developed neutropenic fever requiring hospitalization; no mention of ALT elevations or hepatotoxicity). 7707128
Kurzrock R, Strom SS, Estey E, O'Brien S, Keating MJ, Jiang H, Adams T, et al. Second cancer risk in hairy cell leukemia: analysis of 350 patients. J Clin Oncol 1997; 15: 1803-10. (Among 350 patients with hairy cell leukemia treated and followed for an average of 7 years, secondary cancers occurred in 26 [7%], which was minimally higher than might be expected and was not associated with any specific therapy, interferon, cladribine or pentostatin). 9164188
Fridrik MA, Jär G, Kienzer HR, Hausmaninger H, Oppitz P, Krieger O, Zabernigg A, et al. Efficacy and toxicity of 2-Chlorodeoxyadenosine (Cladribine)--2 h infusion for 5 days--as first-line treatment for advanced low grade non-Hodgkin's lymphoma. Eur J Cancer 1998; 34: 1560-4. (Among 50 patients with non-Hodgkin lymphoma treated with four 5-day courses of cladribine, the major side effect was leucopenia [44%] and infections [14%]; no mention of ALT abnormalities or hepatotoxicity). 9893628
Saven A, Burian C, Koziol JA, Piro LD. Long-term follow-up of patients with hairy cell leukemia after cladribine treatment. Blood 1998; 92: 1918-26. (Long term follow up on 358 patients with hairy cell leukemia treated with cladribine found 91% complete response rate to a single 7 day infusion, 26% relapse rate, 8% occurrence of secondary malignancies; no reported early or delayed hepatic side effects). 9731048
Chadha P, Rademaker AW, Mendiratta P, Kim B, Evanchuk DM, Hakimian D, Peterson LC, et al. Treatment of hairy cell leukemia with 2-chlorodeoxyadenosine (2-CdA): long-term follow-up of the Northwestern University experience. Blood 2005; 106: 241-6. (Among 86 patients with hairy cell leukemia treated with cladribine and followed for a median period of 9 years, 15 [17%] developed a second malignancy, which were largely solid tumors, none developed a secondary leukemia, lymphoma or hematologic malignancy). 15761021
Else M, Ruchlemer R, Osuji N, Del Giudice I, Matutes E, Woodman A, Wotherspoon A, Swansbury J, Dearden C, Catovsky D. Long remissions in hairy cell leukemia with purine analogs: a report of 219 patients with a median follow-up of 12.5 years. Cancer 2005; 104: 2442-8. (Among 219 patients with hairy cell leukemia treated with either cladribine [n=34] or pentostatin [n=185], rates of complete remission [81% vs 82%] and 10 year survival [100% vs 96%] were similar). 16245328
Cannon T, Mobarek D, Wegge J, Tabbara IA. Hairy cell leukemia: current concepts. Cancer Invest 2008; 26: 860-5. (Review of the clinical features, course and therapy of hairy cell leukemia; cladribine and pentostatin are first line therapies for this disease and have similar rates of long term response; infections may be less common with pentostatin, but cladribine is given in a single course, whereas pentostatin must be given as multiple courses). 18798068
Ravandi F, O'Brien S, Jorgensen J, Pierce S, Faderl S, Ferrajoli A, Koller C, et al. Phase 2 study of cladribine followed by rituximab in patients with hairy cell leukemia. Blood 2011; 118: 3818-23. (Among 36 patients with hairy cell leukemia treated with a 5 day course of intravenous cladribine followed one month later by rituximab, all had a complete response with resolution of splenomegaly; adverse events included significant infections in 33%, but there were no nonhematologic severe adverse events and no mention of ALT elevations or hepatotoxicity). 21821712
Jain P, Pemmaraju N, Ravandi F. Update on the biology and treatment options for hairy cell leukemia. Curr Treat Options Oncol 2014; 15: 187-209. (Review of the clinical features, etiology and therapy of hairy cell leukemia, which has been linked to mutations in the BRAF gene [V600E] and, while usually responsive to therapy with cladribine or pentostatin, promising future approaches include inhibitors of the BRAF signaling pathway). 24652320
Donadieu J, Bernard F, van Noesel M, Barkaoui M, Bardet O, Mura R, Arico M, et al.; Salvage Group of the Histiocyte Society. Cladribine and cytarabine in refractory multisystem Langerhans cell histiocytosis: results of an international phase 2 study. Blood 2015; 126: 1415-23.. (Among 27 patients with refractor Langerhans cell histiocytosis treated with the combination of cladribine and cytarabine, the overall response rate was 92% and the major side effect was profound pancytopenia; no mention of ALT elevations or hepatotoxicity, but one patient with severe liver involvement later developed sclerosing cholangitis requiring liver transplantation). 26194764
Stelmasiak Z, Solski J, Nowicki J, Jakubowska B, Ryba M, Grieb P. Effect of parenteral cladribine on relapse rates in patients with relapsing forms of multiple sclerosis: results of a 2-year, double-blind, placebo-controlled, crossover study. Mult Scler. 2009;15:767-70.. (Among 84 patients with multiple sclerosis treated with subcutaneous cladribine [5 mg) or placebo once daily in seven 5-day courses, the mean relapse rate decreased with cladribine from 0.86 to 0.15 vs 1.05 to 0.61, while lymphocyte counts decreased by 60%, “cladribine was well tolerated and had a favorable safety profile”; no mention of ALT levels or hepatotoxicity). 19482866
Giovannoni G, Comi G, Cook S, Rammohan K, Rieckmann P, Soelberg Sørensen P, et al.; CLARITY Study Group. A placebo-controlled trial of oral cladribine for relapsing multiple sclerosis. N Engl J Med. 2010;362:416-26.. (Among 1326 adults with multiple sclerosis treated with cladribine [total dose 3.5 or 5.25 mg/kg] vs placebo in 4 to 6 short courses over 52 weeks, the mean annual rate of relapse at week 96 was 0.14 and 0.15 vs 0.33, while adverse events included lymphocytopenia [22% and 32% vs 1.8%] and herpes zoster [1.9% and 2.6% vs no cases] and serious adverse event rates were 8.4% and 9.0% vs 6.4% which included serious hepatobiliary disorders in 0.7% and 1.3% vs 0.7%). 20089960
Cook S, Vermersch P, Comi G, Giovannoni G, Rammohan K, Rieckmann P, Sørensen PS, et al.; CLARITY Study Group. Safety and tolerability of cladribine tablets in multiple sclerosis: the CLARITY (CLAdRIbine Tablets treating multiple sclerosis orally) study. Mult Scler. 2011;17:578-93.. (In depth analysis of the adverse events that arose in the large, controlled trial of cladribine [3.5 and 5.25 mg/kg] vs placebo in 1326 adults with relapsing multiple sclerosis [Giovannoni 2010], found ALT elevations above 5 times ULN in 1.2% and 0.7% vs 0.9% but all resolved upon stopping, and none were accompanied by elevations in serum bilirubin above twice normal). 21228029
Leist TP, Comi G, Cree BA, Coyle PK, Freedman MS, Hartung HP, Vermersch P, et al.; oral cladribine for early MS (ORACLE MS) Study Group. Effect of oral cladribine on time to conversion to clinically definite multiple sclerosis in patients with a first demyelinating event (ORACLE MS): a phase 3 randomised trial. Lancet Neurol. 2014;13:257-67.. (Among 903 adults with relapsing multiple sclerosis treated with cladribine [3.5 or 5.25 mg/kg total dose] vs placebo, there was a reduction in the risk of conversion to “definite” multiple sclerosis with therapy while adverse event rates were 82% and 81% vs 79%, which were serious in 45% and 50% vs 29%, leading to discontinuation in 5% and 10% vs 4%, while ALT elevations [above 3 or 5 times ULN?] arose in 0% and 0% vs 1%). 24502830
Cook S, Leist T, Comi G, Montalban X, Giovannoni G, Nolting A, Hicking C, et al. Safety of cladribine tablets in the treatment of patients with multiple sclerosis: An integrated analysis. Mult Scler Relat Disord. 2019;29:157-167.. (An integrated review of adverse events in randomized controlled trials and extension studies of 923 recipients of cladribine and 641 placebo controls found increased rates of lymphopenia, but no increase in rates of malignances or infections [except for herpes zoster]; no mention of ALT elevations or hepatotoxicity). 30885374
Giovannoni G, Soelberg Sorensen P, Cook S, Rammohan K, Rieckmann P, Comi G, et al. Safety and efficacy of cladribine tablets in patients with relapsing-remitting multiple sclerosis: Results from the randomized extension trial of the CLARITY study. Mult Scler. 2018;24:1594-1604.. (Among 806 patients with multiple sclerosis who participated in a controlled trial of cladribine [Giovannoni 2010] and were enrolled in an extension study for 2 years, clinical benefits were sustained and no new safety signals arose; no mention of ALT elevations or hepatotoxicity). 28870107
Cladribine (Mavenclad) for multiple sclerosis. Med Lett Drugs Ther. 2019;61(1577):118-120.. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of cladribine shortly after its approval for use in relapsing multiple sclerosis in the United States, discusses adverse events of lymphocytopenia, herpes zoster, infections, and possibility of increased risk of cancer; no mention of ALT elevations or hepatotoxicity but does state that patients should be screened for hepatitis B and C because of risk of reactivation). 31381552
Drugs for multiple sclerosis. Med Lett Drugs Ther 2021; 63(1620): 42-8. (Concise review of the relative clinical efficacy, safety and costs of drugs for relapsing multiple sclerosis including parenteral agents [such as interferon-beta, glatiramer acetate, natalizumab, alemtuzumab, ocrelizumab, ofatumumab, rituximab and mitoxantrone] and the oral agents [such as the S1P receptor modulators, cladribine, fumarates, and teriflunomide], many of which are associated with serum ALT elevations and several have been reported to cause clinically apparent liver injury or reactivation of hepatitis B). 33976089
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880.. (Extensive review of the frequency and characteristics of hepatic injury associated with different disease modifying drugs for multiple sclerosis, mentions that in controlled trials, fingolimod therapy was associated with abnormal liver test elevations in 11% of patients that were above 5 times ULN in 2%, while cases of clinically apparent liver injury were not reported, but that since its approval several cases including 3 cases of acute liver failure leading to emergency liver transplantation have been reported, as have examples of reactivation of hepatitis B and C, so that frequent monitoring of liver tests is recommended). 34319570
McGinley MP, Goldschmidt CH, Rae-Grant AD. Diagnosis and treatment of multiple sclerosis: a review. JAMA. 2021;325:765-779.. (Review of the clinical features, diagnosis, and therapy of multiple sclerosis, discusses nine classes of disease modifying therapies including cladribine, the side effects of which include lymphopenia, herpes zoster and increase risk of cancer, but does not mention hepatoxicity, which the other approved agents all share). 33620411
Oh J, Walker B, Giovannoni G, Jack D, Dangond F, Nolting A, Aldridge J, et al. Treatment-emergent adverse events occurring early in the treatment course of cladribine tablets in two phase 3 trials in multiple sclerosis. Mult Scler J Exp Transl Clin. 2021;7:20552173211024298.. (Among 1277 patients with multiple sclerosis treated in two controlled trials of cladribine [3.5 mg/kg] vs placebo, early onset [within 12 weeks] adverse events were more frequent with cladribine than placebo [61% vs 55%], the most frequent being headache, lymphopenia, and nausea, but serious adverse events arose in only 2.2% vs 1.7% and leading to discontinuation in 1.6% vs 1.4%, including due to ALT elevations in 2 vs 1 participants [0.3% vs 0.2%]). 34345436
Rejdak K, Zasybska A, Pietruczuk A, Baranowski D, Szklener S, Kaczmarek M, Stelmasiak Z. Long-term safety and efficacy of subcutaneous cladribine used in increased dosage in patients with relapsing multiple sclerosis: 20-year observational study. J Clin Med. 2021;10:5207.. (Among 52 patients with multiple sclerosis treated with a subcutaneous, “off-label” formulation of cladribine, 41 of whom were offered chronic maintenance therapy for up to 20 years, cladribine was considered effective and well tolerated; no mention of ALT elevations or hepatotoxicity). 34768726
Barbieri MA, Sorbara EE, Battaglia A, Cicala G, Rizzo V, Spina E, Cutroneo PM. Adverse drug reactions with drugs used in multiple sclerosis: an analysis from the Italian Pharmacovigilance Database. Front Pharmacol. 2022;13:808370.. (Among 13,880 spontaneous reports to Italian pharmacovigilance registries of adverse events attributed to disease modifying therapies for multiple sclerosis between 2002 and 2020, there were marked increase in the annual numbers starting in 2013, but only 72 were attributed to cladribine, most of which were mild and only two were hepatobiliary disorders – most liver events being attributed to fingolimod [n=170], interferon beta [94], dimethyl fumarate [49], natalizumab [42], and teriflunomide [41]). 35281926
Buonomo AR, Viceconte G, Calabrese M, De Luca G, Tomassini V, Cavalla P, Maniscalco GT, et al.; Raising Italian Researchers in Multiple Sclerosis (RIREMS) study group. Management of hepatitis B virus prophylaxis in patients treated with disease-modifying therapies for multiple sclerosis: a multicentric Italian retrospective study. J Neurol. 2022;269:3301-3307.. (Among 931 Italian patients with multiple sclerosis who were being treated with monoclonal anti-CD20 [ocrelizumab or rituximab] or cladribine in 2020 to 2021, 94% had been screened for HBV markers before starting therapy of whom none were HBsAg positive but 53 [6%] were possibly harboring HBV (anti-HBc positive or anti-HBs positive and denied vaccination) of whom 20 received antiviral prophylaxis, but done developed evidence of reactivation of HBV). 35165767
Saraceno L, Pirro F, Stigliano R, Agostoni EC, Protti A. Acute idiosyncratic liver injury after cladribine treatment for multiple sclerosis: first case report and review on associated hepatic disorders. Mult Scler. 2022;28:2142-2145.. (19 year old woman with multiple sclerosis developed rash, nausea, and jaundice 12 days after starting cladribine reponding to a 6-day course of prednisone with rapid improvement and normal liver tests 2 months later). 36169305
Brownlee WJ. Cladribine-induced liver injury: implications for practice. Mult Scler. 2022;28:2146.. (Editorial in response to Saraceno [2022] mentions that 2 cases of liver injury among 2200 patients treated with oral cladribine have been reported to a UK Regulatory Agency making the possibility that cladribine can cause liver injury more likely). 36169282
Sorensen PS, Pontieri L, Joensen H, Heick A, Rasmussen PV, Schäfer J, Ratzer R, et al. Real-world experience of cladribine treatment in relapsing-remitting multiple sclerosis: A Danish nationwide study. Mult Scler Relat Disord. 2023;70:104491.. (Among 268 patients with multiple sclerosis treated with cladribine enrolled in a Danish national registry between 2017 and 2021, during a median follow up of 2.7 years adverse events were reported in 44 patients including 5 referred to and 7 discontinued because of adverse events). 36623393
Velișcu EM, Liguori V, Anatriello A, Maniscalco GT, Cantone A, Di Costanzo L, Stefanelli P, et al. Hepatobiliary adverse reactions during treatment with cladribine: analysis of data from the European Spontaneous Reporting System. Pharmaceuticals (Basel). 2023;16:1071.. (Among 4181 spontaneous adverse event reports made to the European Pharmacovigilance registry as of 2023 , 118 belonged to “hepatobiliary disorders” which included “drug-induced liver injury” [n=14], “ALT increased” [n=11], “liver disorder” [n=11], “hepatotoxicity” [n=8], and “hepatic failure” [n=9], and the proportion of liver related events were higher with cladribine than glatiramer, natalizumab, ofatumumab, dimethyl fumarate, and peginterferon beta). 37630986
Rakers F, Fritsch A, Herrmann A, Tannapfel A, Schwab M. Oral cladribine treatment and idiosyncratic drug-induced liver injury in multiple sclerosis. BMJ Neurol Open. 2023;5:e000481.. (35 year old woman with multiple sclerosis developed acute hepatocellular injury with jaundice 10 weeks after starting cladribine and 6 weeks after a 3-day course of 400 mg of prednisolone [bilirubin 31 rising to 45 mg/dL, ALT 912 U/L, Alk P normal] which resolved within 2 months of stopping, but she later tolerated restarting cladribine without recurrence). 37705760
Biolato M, Bianco A, Giustiniani MC, Mirabella M, Pompili M. A case report of cladribine-induced IgG4-associated liver injury. Acta Neurol Belg. 2024;124:1695-1697.. (42 year old woman with multiple sclerosis developed jaundice 2 weeks after starting cladribine and 1 month after a 5-day course of high dose methylprednisolone [bilirubin 17 rising to 20.5 mg/dL, ALT 1463 U/L, Alk P 164 U/L, INR 1.9] with rapid resolution with oral prednisone). 38587719
Giovannoni G, Boyko A, Correale J, Edan G, Freedman MS, Montalban X, Rammohan K, et al. Long-term follow-up of patients with a first clinical demyelinating event (clinically isolated syndrome) who received cladribine tablets in CLASSIC-MS: Findings for the ORACLE-MS cohort. Mult Scler. 2025;31:44-58.. (Among 227 patients with a first demyelinating event enrolled in placebo controlled studies of cladribine who were then followed for a median of 9.5 years, conversion to definite multiple sclerosis occurred in 55% [median time 7.6 years] of those treated with cladribine vs 81% [median time 1.4 years] who were never treated; no discussion of adverse events). 39690897
Sönmez MT, Yetkin MF, Mehdiyev DA, Köseoğlu M, Mungan S, Kale N, Terzi M, et al. Safety and efficacy of cladribine in patients discontinuing fingolimod due to elevated transaminase levels: The FinClad Study. Mult Scler Relat Disord. 2025;101:106578.. (Among 45 patients with multiple sclerosis who switched from fingolimod to cladribine therapy because of serum aminotransferase elevations, both ALT and AST fell into the normal range in all patients and 87% “maintained effective disease control”). 40570400
Hu Y, He J, Tu Z, Ye H, Zhuang C, Jin Z, Hu H, et al. Post-marketing safety profile of cladribine in multiple sclerosis: a disproportionality analysis based on the FDA adverse event reporting system. Int J Clin Pharm. 2025 Nov 15. Epub ahead of print.. (Among 4833 spontaneous adverse event reports on cladribine made to the FDA’s Adverse Event Reporting System [FAERS] made between 2019 and 2024, 75% were in women and many were for pneumonia [n=190] and lymphopenia [111], while 22 were for liver injury and 60 for ALT elevations). 41240270
Monschein T, Untersteiner H, Ponleitner M, Krajnc N, Zrzavy T, Bsteh G, Rommer P, et al.; Austrian MS Treatment Registry (AMSTR). Safety of disease-modifying therapies in multiple sclerosis: real-world data from the Austrian MS Treatment Registry (AMSTR). J Neurol. 2025;272:774.. (Among 7913 patients enrolled in the Austian multiple sclerosis therapy registry between 2006 and 2025, adverse event reports were received on 35 [8%] of 458 enrolled patients receiving cladribine, which were mostly infections [21] including herpes zoster [10], while “hepatobiliary disorders” were reported in 3 [0.7% of enrollees]). 41258942
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, one case was attributed to fingolimod and one to natalizumab, but no other agents used to treat multiple sclerosis were listed: personal communication). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Cladribine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cladribine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Cladribine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cladribine)